# Cytarabine

## OVERVIEW

### Introduction

Cytarabine is a cytosine analogue and antineoplastic agent used largely in the therapy of acute leukemia. Cytarabine is associated with a low rate of transient serum enzyme and bilirubin elevations during therapy, but has only rarely been implicated in cases of clinically apparent acute liver injury with jaundice.

### Background

Cytarabine (sye tar' a been) is an nucleoside analogue (cytosine arabinoside: ara-C) which is converted intracellularly to a triphosphate, which competes with cytosine triphosphate for incorporation into RNA and DNA and acts as an inhibitor of RNA and DNA polymerase, thus blocking DNA synthesis and cell division. Cytarabine has potent activity in acute leukemia and was approved for use in the United States in 1969 and is still widely used. Current indications include initial, consolidation and maintenance therapy of acute myelogenous and other acute leukemias. Cytarabine is available in vials of 100, 500, 1000 and 2000 mg (20 mg/mL) for intravenous or intrathecal infusion generically and under the brand name Cytosar-U. Liposomal sustained release formulations are also available for intrathecal administration (DepoCyt). The dose regimen of cytarabine varies by body surface area and indication. A typical induction dose is 100 mg per meter squared by continuous intravenous infusion on days 1 to 7. Common side effects include bone marrow suppression, nausea, vomiting, oral or anal ulcers, abdominal pain, myalgias, bone pain, chest pain, conjunctivitis headache, fatigue, fever, rash and pruritus.

### Hepatotoxicity

Serum aminotransferase elevations occur in 5% to 10% of patients on conventional doses of cytarabine and a greater proportion (9% to 75%) at higher doses. However, the serum enzyme elevations are rarely associated with symptoms and are generally self-limited and resolve rapidly, rarely requiring dose modification. Cases of clinically apparent liver injury attributed to cytarabine have been reported but are uncommon. The time to onset was usually within the first few cycles of therapy, and the pattern of serum enzyme elevations ranged from cholestatic to hepatocellular. Immunoallergic and autoimmune features were generally not present. Antineoplastic regimens, including cytarabine, have been implicated in cases of sinusoidal obstruction syndrome and peliosis, but the role of cytarabine in these reactions was unclear. Many examples of liver injury attributed to cytarabine in the literature were typical of jaundice of sepsis rather than acute hepatocellular or cholestatic injury, although high doses of cytarabine may cause hyperbilirubinemia independent of hepatic injury.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

While hepatotoxicity from cytarabine may be rare, it is likely due to direct toxicity to hepatocytes. Cytarabine is metabolized in the liver via the cytochrome P450 system and production of a toxic or immunogenic intermediate may trigger liver injury.

### Outcome and Management

The severity of the liver injury linked to cytarabine therapy is usually mild and self-limited. Cytarabine has been linked to cases of acute liver failure but the relationship to cytarabine has not always been clear. Cytarabine has not been linked chronic hepatitis or vanishing bile duct syndrome. The product label for cytarabine recommends "periodic checks" of bone marrow, renal and kidney function" during therapy. There is no information on cross sensitivity to hepatic injury between cytarabine and other pyrimidine analogues.

Drug Class: Antineoplastic Agents

Other Drugs in the Subclass, Pyrimidine Analogues: Azacitidine, Capecitabine, Decitabine, Floxuridine, Fluorouracil, Gemcitabine, Trifluridine/Tipracil

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cytarabine – Generic, Cytosar-U®, DepoCyt®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Cytarabine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Cytarabine | 147-94-4 | C9-H13-N3-O5 | Cytarabine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 03 November 2017

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; mentions that the hepatotoxic effects of cytarabine appear to be dose related, AST elevations occurring in 5-10% of patients at lowest and 22-75% at highest doses, which are also associated with occasional cases of clinically apparent cholestatic or hepatocellular injury).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 549-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; mentions that cytarabine has been implicated in case reports of cholestatic hepatitis and peliosis).
Chabner BA, Bertino J, Clearly J, Ortiz T, Lane A, Supko JG, Ryan DP. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1315-404. (Textbook of pharmacology and therapeutics; states that cytarabine is the most effective agent in therapy of acute myelogenous leukemia [AML]).
Ellison RR, Holland JF, Weil M, Jacquillat C, Boiron M, Bernard J, Sawitsky A, et al. Arabinosyl cytosine: a useful agent in the treatment of acute leukemia in adults. Blood 1968; 32: 507-23. (In an early dose regimen finding study, serum bilirubin elevations occurred in 10-15% of patients treated with cytarabine, but were largely due to sepsis or hemolytic reactions; there were also "minor variations" in AST and Alk P that resolved with stopping therapy and did not recur on restarting). 4879053
Bodey GP, Freireich EJ, Monto RW, Hewlett JS. Cytosine arabinoside(NSC-63878) therapy for acute leukemia in adults. Cancer Chemother Rep 1969; 53: 59-66. (Among patients with refractory leukemia who received 5 day courses of cytarabine, elevations in AST occurred during 9 of 42 courses, but all resolved rapidly and no patient developed symptoms or jaundice). 5772656
Cytarabine (Cytosar). Clin Pharmacol Ther 1970; 11: 155-60. (Initial product labeling of cytarabine shortly after its initial approval for use in the US; hepatic dysfunction is said to occur during treatment in 7.1% of adults and 5.5% of children; cytarabine "is suspected of being hepatotoxic, but this is unproven"). 5262667
Wang JJ, Selawry OS, Vietti TJ, Bodey GP Sr. Prolonged infusion of arabinosyl cytosine in childhood leukemia. Cancer 1970; 25: 1-6. (46 children with refractory acute leukemia were treated with 5 day courses of intravenous cytarabine [1.2 g/m^2^ daily] every two weeks; side effects included myelosuppression, nausea, vomiting, anorexia, diarrhea, phlebitis and mild elevations in aminotransferase levels in 2 patients [~5%]). 5262259
Burke PJ, Owens AH Jr, Colsky J, Shnider BI, Edmonson JH, Schilling A, Brodovsky HS, Wallace HJ Jr, Hall TC. A clinical evaluation of a prolonged schedule of cytosine arabinoside (NSC63878). Cancer Res 1970; 30: 1512-5. (Among 85 patients with metastatic cancer treated with cytarabine in repeated 10 day courses, "moderate and transient" elevations in liver tests occurred in some patients). 5426952
Traggis DG, Dohlwitz A, Das L, Jaffe N, Moloney WC, Hall TC. Cytosine arabinoside in acute leukemia of childhood. Cancer 1971; 28: 815-8. (Among 74 children with acute leukemia treated with intravenous cytarabine [25 mg/kg] twice weekly, 4 developed jaundice, but all resolved with dose modification; few details given). 5286443
Hryniuk W, Foerster J, Shojania M, Chow A. Cytarabine for herpesvirus infections. JAMA 1972; 219: 715-8. (Among 7 patients with severe herpesvirus infections [varicella-zoster and herpes simplex] treated with cytarabine, serum AST and LDH levels rose "transiently and slightly" during the first 48 hours of infusion in 4 patients, but isoenzyme testing suggested that the enzymes were not hepatic in origin). 4333390
Griner PF, Elbadawi A, Packman CH. Veno-occlusive disease of the liver after chemotherapy of acute leukemia. Report of two cases. Ann Intern Med 1976; 85: 578-82. (Two patients with acute leukemia developed fatal sinusoidal obstruction syndrome after combination cyclic chemotherapy; the only two agents that both had received were thioguanine and cytarabine, thioguanine being the more likely culprit). 1068643
Cassileth PA, Katz ME. Chemotherapy for adult acute nonlymphocytic leukemia with daunorubicin and cytosine arabinoside. Cancer Treat Rep 1977; 61: 1441-5. (Among 21 adults with acute leukemia treated with cytarabine and daunorubicin, one-third had bilirubin elevations after the initial course, but serum enzymes were normal and the elevations did not recur with a second course). 922749
Herzig RH, Wolff SN, Lazarus HM, Phillips GL, Karanes C, Herzig GP. High-dose cytosine arabinoside therapy for refractory leukemia. Blood 1983; 62: 361-9. (Among 57 patients with refractory leukemia treated with high doses of cytarabine [3 g/m2 every 12 hours], elevations in liver tests occurred in almost all patients and were moderate in severity in 75%, but severe only in those with longer courses of therapy). 6223674
Pizzuto J, Avilés A, Ramos E, Cervera J, Aguirre J. Cytosine arabinoside induced liver damage: histopathologic demonstration. Med Pediatr Oncol 1983; 11: 287-90. (A 50 year old woman and 33 year old man with AML were treated with cycles of cytarabine [dose not given], vincristine and prednisone and developed liver test elevations after the second course [peak direct bilirubin ~10 and 5 mg/dL, AST ~1000 and 475 U/L], with greater elevations after a third course, resolving rapidly after stopping, and biopsies showing mild nonspecific inflammation and focal necrosis). 6577264
George CB, Mansour RP, Redmond J 3rd, Gandara DR. Hepatic dysfunction and jaundice following high-dose cytosine arabinoside. Cancer 1984; 54: 2360-2. (Two men, ages 45 and 31, with refractory leukemia were treated with high doses of cytarabine [3 g/m2 every 12 hours for 6 days] and developed jaundice within 2 weeks [bilirubin 21 and 23 mg/dL, AST 29 and 10 U/L, Alk P 393 and 103 U/L], both dying of septic shock before recovery; autopsy showed passive congestion and minimal changes). 6594185
Donehower RC, Karp JE, Burke PJ. Pharmacology and toxicity of high-dose cytarabine by 72-hour continuous infusion. Cancer Treat Rep 1986; 70: 1059-65. (28 patients with refractory leukemia received varying doses of cytarabine [4 to 24 g/m^2^ over 72 hours], enzymes elevations occurred in 89% and values greater than 5 times ULN in 7%; "The toxicity of this schedule...was formidable at the higher doses"). 3461882
Kantarjian HM, Estey EH, Plunkett W, Keating MJ, Walters RS, Iacoboni S, McCredie KB, Freireich EJ. Phase I-II clinical and pharmacologic studies of high-dose cytosine arabinoside in refractory leukemia. Am J Med 1986; 81: 387-94. (Among 64 patients with refractory leukemia treated with high dose cytarabine [3 g/m^2^ every 12 hours for 4-12 doses], liver tests abnormalities occurred in 14 [2%] and were severe in 3 [2%]). 3463209
Sznol M, Ohnuma T, Holland JF. Hepatic toxicity of drugs used for hematologic neoplasia. Semin Liver Dis 1987; 7: 237-56. (Review of the hepatotoxicity of drugs used to treat leukemia mentions that low doses of cytarabine cause mild serum enzyme elevations in 5-10% of patients, but that higher doses can cause abnormalities with jaundice in a high proportion of patients). 3317861
Bolwell BJ, Cassileth PA, Gale RP. Low dose cytosine arabinoside in myelodysplasia and acute myelogenous leukemia: a review. Leukemia 1987; 1: 575-9. (Systematic review of "low dose" cytarabine therapy of AML and myelodysplasia, identified 463 patients in 10 studies; toxicity was largely due to myelosuppression, and "there were no reports of cerebellar or hepatic toxicity" which were common with high dose therapy). 3312846
Bolwell BJ, Cassileth PA, Gale RP. High dose cytarabine: a review. Leukemia 1988; 2: 253-60. (Systematic review of results of trials of high dose cytarabine therapy in acute leukemia, toxicities include prolonged pancytopenia, cerebellar dysfunction, peripheral neuropathy and gastrointestinal problems including abnormal liver tests in 9-72% of patients, which are usually mild and reversible, but two deaths associated with cholestatic jaundice have been reported [George 1984]). 3287015
Tanaka H, Kawakami M, Kuraishi Y, Meguro S, Ishikawa E. A comparative pathological study of liver injury after different combination chemotherapies for leukemia. Acta Pathol Jpn 1988; 38: 1417-32. (Use of a regimen of daunorubicin, cytarabine, mercaptopurine and prednisone was associated with a distinctive hepatic injury marked by irreversible liver cell injury and hemosiderosis that was no longer seen once thioguanine was used instead of mercaptopurine). 3223277
Hashimoto M, Seekikawa I, Saito K, Horie S, Ishiyama T, Sugimoto M, Wakabayashi Y, Hirose S. [Acute leukemia complicated by hyperbilirubinemia due to high dose cytosine arabinoside therapy]. Rinsho Ketsueki 1989; 30: 262-5. Japanese. (Abstract: 58 year old man with acute leukemia developed jaundice with normal ALT levels after a course of cytarabine, autopsy showing cholestasis without necrosis). 2746881
Kirtley DW, Votaw ML, Thomas E. Jaundice and hepatorenal syndrome associated with cytosine arabinoside. J Natl Med Assoc 1990; 82: 209, 213, 217-8. (28 year old man with acute leukemia in relapse was treated with cytarabine [3 g/m^2^ every 12 hours for 9 doses], developing fever and jaundice [bilirubin 9.2 rising to 45 mg/dL, ALT 88 U/L, Alk P 55 U/L], followed by progressive multiorgan failure and dying within 11 days of starting therapy; autopsy showed bile stasis and centrolobular steatosis). 2319616
Nachbaur K, Dietze O, Herold M, Thaler J, Braunsteiner H, Vogel W. Fulminant hepatic failure after high-dose cytosine arabinoside and mitoxantrone treatment for relapse of acute myelogenous leukaemia. Eur J Haematol 1992; 49: 221-3. (15 year old girl with relapse of AML given high dose cytarabine and mitoxantrone developed progressive rise in ALT 14 days after chemotherapy [bilirubin 2.2 mg/dL, ALT 110 rising to 3330 U/L, Alk P 324 U/L, LDH 15030 U/L], with hepatic coma and death, autopsy showing massive centrolobular necrosis). 1464366
Wysocki M, Nowaczyk-Michalak A, Pilecki O, Trybu. L, Balcar-Boro. A. Jaundice following high-dose arabinoside cytosine in a child with acute myelogenous leukemia. Acta Haematol Pol 1992; 23: 197-9. (Child with AML developed jaundice after 3rd and 4th course of cytarabine, which resolved on stopping therapy). 1492544
Faggioli P, De Paschale M, Tocci A, Luoni M, Fava S, De Paoli A, Tosi A, et al. Acute hepatic toxicity during cyclic chemotherapy in non Hodgkin's lymphoma. Haematologica 1997; 82: 38-42. (Among 98 Italian patients with lymphoma treated with cyclic chemotherapy [7 receiving cytarabine with other agents], 12 developed acute hepatitis including 8 of 22 who were HBsAg positive, 1 of 11 anti-HCV positive, but only 3 of 76 negative for both markers). 9107080
Tanaka M, Kanamori H, Yamaji S, Mishima A, Fujita H, Fujisawa S, Murata T, et al. Low-dose cytarabine-induced hepatic and renal dysfunction in a patient with myelodysplastic syndrome. Anticancer Drugs 1999; 10: 289-91. (48 year old woman with myelodysplasia developed fever after 12 days during an initial course of subcutaneous cytarabine [every 12 hours], with rapid recurrence on restarting followed by renal and hepatic injury [bilirubin 1.3 mg/dL, ALT 232 U/L, creatinine 4.4], which resolved upon stopping and reoccurred again rapidly with an attempt at a third course). 10327034
Altundag O, Altundag K, Celik I, Turker A, Kars A. Isolated hyperbilirubinemia following standard dose cytosine arabinoside in a patient with relapsed acute myeloid leukemia. Am J Hematol 2004; 75: 263-4. (56 year old woman with relapsed AML developed sepsis and jaundice 11 days after starting cytarabine and idarubicin [bilirubin 12.5 rising to 42.9 mg/dL, ALT 0 U/L, Alk P 145 U/L], resolving with resolution of neutropenia). 15054828
Babaoglu MO, Karadag O, Saikawa Y, Altundag K, Elkiran T, Yasar U, Bozkurt A. Hepatotoxicity due to a possible interaction between cytosine arabinoside and dipyridamole: a case report. Eur J Clin Pharmacol 2004; 60: 455-6. (52 year old man with relapse of acute leukemia was treated with high dose cytarabine while receiving dipyridamole, and developed fever and jaundice and died of septic shock; the authors hypothesize interaction between the two drugs resulting in higher cytarabine levels). 15232664
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports [89% from the US]; cytarabine was associated with 53 cases). 16054882
Coutsouvelis J, Corallo CE. The management of prolonged, isolated hyperbilirubinemia following cytarabine-based chemotherapy for acute myeloid leukaemia. J Oncol Pharm Pract 2009; 15: 107-10. (47 year old man with AML developed jaundice with normal ALT and Alk P levels after a course of cytarabine, idarubicin and etoposide [bilirubin 1.6 on day 8 rising to 14.9 mg/dL on day 26], course complicated by sepsis and hypotension). 18818219
Advani AS, McDonough S, Coutre S, Wood B, Radich J, Mims M, O'Donnell M, et al. SWOG S0910: a phase 2 trial of clofarabine/cytarabine/epratuzumab for elapsed/refractory acute lymphocytic leukaemia. Br J Haematol 2014; 165: 504-9. (Among 35 adults with refractory ALL treated with clofarabine, cytarabine and epratuzumab [anti-CD22], the response rate was 52%, but adverse events were common, including ALT elevations above 5 times ULN in 11 patients [31%], one of whom had "hepatic failure", but there were no liver related deaths). 24579885
Martínez-Cuadrón D, Montesinos P, Oriol A, Salamero O, Vidriales B, Bergua J, Herrera P, et al. Phase II trial to assess the safety and efficacy of clofarabine in combination with low-dose cytarabine in elderly patients with acute myeloid leukemia. Ann Hematol 2014; 93: 43-6. (Among 11 elderly adults with AML treated with clofarabine with low doses of cytarabine, the response rate was 27%, but the mortality rate rose to 73% at 8 weeks and one death was attributed to hepatic and renal failure). 24081577
Donadieu J, Bernard F, van Noesel M, Barkaoui M, Bardet O, Mura R, Arico M, et al; Salvage Group of the Histiocyte Society. Cladribine and cytarabine in refractory multisystem Langerhans cell histiocytosis: results of an international phase 2 study. Blood 2015; 126: 1415-23. (Among 27 patients with refractory Langerhans cell histiocytosis treated with two 5-day courses of cytarabine and cladribine, the major toxicities were pancytopenia and sepsis; no mention of ALT elevations or hepatotoxicity). 26194764
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 [5.5%] were attributed to antineoplastic agents, but none were due to cytarabine). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Cytarabine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Cytarabine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Cytarabine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cytarabine)